# Kelp

## OVERVIEW

### Introduction

Kelp is a form of seaweed belonging to the order Laminariales that is used as a food and a source of vitamins and minerals, administered as a botanical supplement, and employed in food processing and production of fertilizers. Preparations of kelp are generally recognized as safe, and there is no evidence that they can cause elevations in liver related enzymes or clinically apparent liver injury.

### Background

Kelp is a seaweed that grows in nutrient rich coastal waters in temperate and subtropical zones of the world. Kelp is a subgroup of seaweed and refers to several genera of the order Laminariales. The kelp most commonly found in the United States is Laminaria hyperborea. Kelp has multiple uses including as a food, as a colloidal gel in toothpaste and ice cream, as a botanical medication, and as a source of nitrogen and phosphate in fertilizer. Kelp is not a plant, but rather brown algae that grows like a plant in long branches (thalluses) in forests near shorelines. The constituents of kelp include salts of alginic acid (laminaric acid: 25%), carbohydrates (laminarin, mannitol, fucoidan, and others: 55%) and minerals and trace elements typically found in coast waters. Kelp is particularly rich in iodine but can also take up other metals and minerals from the ocean such as calcium, iron, mercury, lead, cadmium and even arsenic. Use of kelp as a major food source can lead to thyroid abnormalities and even metal poisoning. Kelp preparations have been used in several traditional medicine systems, and while not approved as therapy of any disease or medical condition, it is available in many over-the-counter formulations purported to be helpful in improving wellness, hair and nail growth, high blood sugar, high blood pressure, migraine headaches, ulcer symptoms, indigestion, and constipation. There is no reliable data on adverse events from kelp and it is designated as “generally recognized as safe” (GRAS), although in large doses it can be harmful in thyroid conditions and have interactions with some prescription medications. Kelp was previously thought to help induce uterine contractions and was used in attempts to induce abortion. There have been no large scale clinical trials that have reported on adverse events associated with use of kelp preparations.

Related to kelp is Ecklonia kurome, a brown alga seaweed that is the source of oligomannate, a short acidic oligosaccharide made from the polysaccharides of Ecklonia kurome by digestion to shorter chains. In cell culture and in animal models of Alzheimer disease, oligomannate demonstrated activity against brain injury and neuroinflammation. A series of clinical trials of oligomannate therapy of Alzheimer disease conducted in China demonstrated improvement of some surrogate markers of Alzheimer disease progression, and it was approved for human use in China in 2018. Similar trials were initiated in international trials but were suspended because of poor enrollment during the COVID pandemic. Oligomannate had few side effects that were generally mild and no more common than with placebo therapy.

### Hepatotoxicity

While kelp is generally recognized as safe, it has not been formally assessed for hepatic adverse effects or elevations of serum aminotransferase, alkaline phosphatase, or bilirubin levels. However, despite common use, there have been no published case reports of liver injury convincingly attributed to kelp. Large case series of liver injury due to herbal and dietary supplements do not mention or list kelp as a possible cause. In contrast, there have been several clinical trials of oligomannate, a derivative of the seaweed species, Ecklonia kurome. In these studies that included 1072 patients with Alzheimer disease, serum ALT elevations arose in 1.7% of subjects on oligomannate vs 0.4% on placebo, and bilirubin elevations in 1.2% vs 0.2% on placebo. A few patients discontinued therapy early because of serum aminotransferase elevations. However, no episodes of hepatotoxicity or clinically apparent liver injury with jaundice were reported.

Kelp likelihood score: E (unlikely cause of clinically apparent liver injury).

Oligomannate likelihood score: E* (unproven but suspected rare cause of liver injury).

Drug Class: Herbal and Dietary Supplements

Other Names: Seaweed, Brown algae, Laminaria hyperborea

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Kelp – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Laminaria Hyperborea | 90046-13-2 (https://pubchem.ncbi.nlm.nih.gov/compound/Laminaria-hyperborea) | Not Available | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 March 2024

Abbreviations: AOSC, acidic oligosaccharide sugar chain; DILI, drug induced liver injury; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not seaweed or kelp).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of seaweed or kelp).
Kelp. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 496-497. (Compilation of short monographs on herbal medications and dietary supplements, mentions that kelp is generally considered as safe and that “no health hazards or side effects are known in conjunction with the proper administration…”).
Hu J, Geng M, Li J, Xin X, Wang J, Tang M, Zhang J, et al. Acidic oligosaccharide sugar chain, a marine-derived acidic oligosaccharide, inhibits the cytotoxicity and aggregation of amyloid beta protein. J Pharmacol Sci. 2004;95:248–255. (Acidic oligosaccharide sugar chain [AOSC] is a derivative of brown algae seaweed Echlonia kurome Okam polysaccharide, which is digested to a smaller linear oligosaccharides of approximately 1300 molecular weight, prevented beta amyloid fibril formation in vitro and decreased the toxicity of beta amyloid aggregates to neuronal cells in culture). 15215650
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. 2009;18:1039–1047. (Among 778 spontaneous reports of adverse reactions to herbal and alterative medicines to a national Swedish Registry, no cases were attributed to seaweed or kelp). 19650152
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. 2012;32:1543–1556. (A systematic compilation of all publications on the hepatotoxicity of specific herbal products identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention kelp). 22928722
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. 2013;17:715–735. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies; no mention of seaweed or kelp). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Rleddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. 2014;60:1399–1408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to seaweed or kelp). 25043597
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. 2017;107:472–501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss seaweed or kelp). 27402097
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495–1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], no mention of seaweed or kelp). 29307848
Wang X, Sun G, Feng T, Zhang J, Huang X, Wang T, Xie Z, et al. Sodium oligomannate therapeutically remodels gut microbiota and suppresses gut bacterial amino acids-shaped neuroinflammation to inhibit Alzheimer’s disease progression. Cell Res. 2019;29:787–803. (In a mouse model of Alzheimer disease, sodium oligomannate changed gut microbiota and decreased neuroinflammation). 31488882
Syed YY. Sodium Oligomannate: first approval. Drugs. 2020;80:441–444. (Summary of the structure, proposed mechanisms of action, clinical efficacy, and toxicity of sodium oligomannate shortly after its approval as therapy of Alzheimer disease in China mentions that safety studies in 577 treated patients and 495 controls yielded low rates of treatment related adverse events in both groups [15% vs 18%], and elevations in ALT arose in 1.9% vs 0.4% and bilirubin in 1.2% vs 02%). 32020555
Wang T, Kuang W, Chen W, Xu W, Zhang L, Li Y, Li H, et al. A phase II randomized trial of sodium oligomannate in Alzheimer’s dementia. Alzheimers Res Ther. 2020;12:110. (Among 242 patients with Alzheimer dementia treated with oligomannate [600 or 900 mg] or placebo daily for 24 weeks, improvements were more frequent with the higher dose, while adverse event rates were similar in the three groups; no mention of ALT elevations or hepatotoxicity). 32928279
Xiao S, Chan P, Wang T, Hong Z, Wang S, Kuang W, He J, et al. A 36-week multicenter, randomized, double-blind, placebo-controlled, parallel-group, phase 3 clinical trial of sodium oligomannate for mild-to-moderate Alzheimer’s dementia. Alzheimers Res Ther. 2021;13:62. (Among 818 Chinese adults with mild-to-moderate Alzheimer disease treated with oligomannate [450 mg] or placebo twice daily for 36 weeks, improvements in the Alzheimer Disease Assessment Scale were greater with oligomannate [21.3 to 18.3] than placebo [20.8 to 20.5] while scores for two other scales did not differ; adverse event rates were similar in the two groups [75% vs 74%] and there were no episodes of clinically apparent liver injury, although several patients in both groups developed cholecystitis). 33731209
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490–5513. (Systematic review of the literature on HDS induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62], and greater celandine [48]; kelp and seaweed were not listed or discussed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548–e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American Drug-Induced Liver Injury Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5], and garcinia [n=3]; seaweed and kelp are not mentioned). 33434654
Yeo-Teh NSL, Tang BL. A review of scientific ethics issues associated with the recently approved drugs for Alzheimer’s disease. Sci Eng Ethics. 2023;29:2. (Discussion of the ethics of accelerated approval of drugs for Alzheimer disease questioning the appropriateness in view of their marginal beneficial effects in registration randomized controlled trials). 36625928

## OTHER REFERENCE LINKS

Recent References on Kelp: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Kelp+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Kelp: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Kelp)